# Oxaliplatin

## OVERVIEW

### Introduction

Oxaliplatin is an intravenously administered platinum containing alkylating agent which is used for the treatment of advanced colorectal cancer. Oxaliplatin therapy is associated with a low rate of transient serum aminotransferase elevations, but is commonly associated with sinusoidal and vascular injury to the liver which can lead to sinusoidal obstruction syndrome and to nodular regenerative hyperplasia with noncirrhotic portal hypertension.

### Background

Oxaliplatin (ox al" i pla' tin) is a cisplatin analog with a tetravalent platinum molecule which is referred to as a platinum coordination complex. Oxaliplatin acts as an alkylating agent causing cross linking between and within DNA strands leading to inhibition of DNA, RNA and protein synthesis and the triggering of programmed cell death, mostly in rapidly dividing cells. Oxaliplatin was approved for use in cancer chemotherapy in the United States in 2002. Its current indications are colorectal carcinoma and it is usually administered in combination with other agents such as 5-fluorouracil (5-FU), irinotecan or capecitabine. Oxaliplatin is available in an aqueous solution for injection in 50, 100 and 200 mg vials in generic forms and under the brand name Eloxatin. The typical dose regimen is a single infusion of oxaliplatin (85 mg/m^2^) on day 1 of each two-week course with leucovorin and 5-FU. Oxaliplatin should be administered only by health care professions with knowledge and experience in using cancer chemotherapeutic agents and in management of their complications. The platinum based antineoplastic agents have similar toxicities, including nausea and vomiting, diarrhea, bone marrow suppression, as well as neuro-, oto- and nephrotoxicity. They are also mutagenic, teratogenic and carcinogenic, and their use has been associated with an increased risk of secondary leukemias. Uncommon but potentially severe adverse events include anaphylaxis, neuropathy, interstitial pulmonary disease and fibrosis, hepatotoxicity and embryo-fetal toxicity.

### Hepatotoxicity

Mild and transient elevations in serum aminotransferase levels are found in an appreciable proportion of patients taking oxaliplatin, but their relationship to oxaliplatin is often unclear. Chemotherapy with oxaliplatin has been associated with histological changes in the liver marked by sinusoidal dilatation, congestion and centrolobular necrosis indicative of sinusoidal obstruction syndrome. These changes are usually mild-to-moderate in severity and not clinically significant during the acute phase, but they can progress to clinically apparent sinusoidal obstruction syndrome or, with chronic therapy, to nodular regenerative hyperplasia with splenomegaly, thrombocytopenia and esophageal varices. Nodular regenerative hyperplasia typically requires 6 to 18 months to develop and arises after repeated cycles of chemotherapy with oxaliplatin. Serum enzyme and bilirubin elevations are minimal, the major laboratory finding being a progressive and persistent thrombocytopenia reflecting the development of splenomegaly and portal hypertension. The first clinical evidence of nodular regenerative hyperplasia may be ascites, esophageal variceal hemorrhage or hepatic encephalopathy. Attempts at hepatic resection, severe gastrointestinal bleeding and septicemia may trigger hepatic decompensation and liver failure. Interestingly, nodular regenerative hyperplasia and portal hypertension tend to improve slowly once chemotherapy is stopped, but the long term consequences of the changes are not well defined.

Likelihood score: A (well established cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of sinusoidal dilatation and central congestion after oxaliplatin therapy is unknown, but probably relates to injury to sinusoidal endothelial lining cells. While described largely after oxaliplatin therapy, similar changes may occur after therapy with the other platinum coordination complexes, alkylating agents and antimetabolites.

### Outcome and Management

The majority of instances of sinusoidal dilatation, vascular injury and congestion found histologically after oxaliplatin therapy occur without significant serum enzyme elevations or clinically apparent liver injury. Rare instances of acute onset of sinusoidal obstruction syndrome with ascites and hepatic failure have been described after oxaliplatin therapy, but usually when given in combination with other antineoplastic agents. Repeated cycles of oxaliplatin and chronic therapy have been linked to nodular regenerative hyperplasia which can be associated with portal hypertension and complications of ascites, variceal hemorrhage and hepatic encephalopathy. There is likely to be cross sensitivity to liver toxicities of the various platinum coordination complexes and continued use or rechallenge after clinically apparent liver injury from oxaliplatin should be avoided. Routine monitoring of liver tests is recommended during courses of oxaliplatin therapy, but evidence of portal hypertension is better assessed using serial platelet counts or repeated radiologic evaluation of spleen size.

Drug Class: Antineoplastic Agents, Alkylating Agents

Other Drugs in the Subclass, Platinum Coordination Complexes: Carboplatin, Cisplatin

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Oxaliplatin – Generic, Eloxatin®

DRUG CLASS

Antineoplastic Agents, Alkylating Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Oxaliplatin)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Oxaliplatin | 61825-94-3 | C8-H14-N2-O4-Pt

## ANNOTATED BIBLIOGRAPHY

References updated: 12 September 2020

Abbreviations: BMI, body mass index; CT, computerized tomography; NRH, nodular regenerative hyperplasia; SOS, sinusoidal obstruction syndrome; HVPG, hepatic venous pressure gradient; SAMe, S-adenosylmethionine.
Zimmerman HJ. Oncotherapeutic and immunosuppressive agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 673-708. (Expert review of hepatotoxicity of cancer chemotherapeutic agents published in 1999; mentions that cisplatin had been reported to cause dose related serum enzyme elevations and has been linked to steatosis and necrosis, whereas carboplatin has been linked to rare instances of cholestatic and hepatocellular injury; oxaliplatin not discussed).
DeLeve LD. Liver sinusoidal endothelial cells and liver injury. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, p. 139-43. (Review of liver injury to sinusoidal endothelial cells caused by medications mentions that oxaliplatin as capable of causing sinusoidal dilatation, peliosis hepatis, nodular regenerative hyperplasia and sinusoidal obstruction syndrome).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Cytotoxic agents. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1167-201. (Textbook of pharmacology and therapeutics).
Jones RJ, Lee KS, Beschorner WE, Vogel VG, Grochow LB, Braine HG, Vogelsang GB, et al. (1987). Veno-occlusive disease of the liver following bone marrow transplantation. Transplantation. (Among 235 patients undergoing bone marrow transplantation between 1982 and 1985, SOS developed in 52 [22%] of whom half died, making SOS the third most common cause of death in this population).
Washington K, Lane KL, Meyers WC. (1993). Nodular regenerative hyperplasia in partial hepatectomy specimens. Am J Surg Pathol. (Pathological review of liver resections from 72 patients showed nodular regenerative hyperplasia in 5, all of whom had colon cancer metastases and had been treated with chemotherapy: usually 5-fluorouracil; 9 patients had hyperplastic foci some of whom had received cisplatin and other agents including cyclophosphamide, VP-16 and carmustine).
Hartmann JT, Lipp H-P. (2003). Toxicity of platinum compounds. Expert Opin Pharmacother. (Review of pharmacology, mechanism of action, adverse effects and tolerance of platinum containing alkylating agents; "Mild reversible increases in liver function tests can occur in patients who have received platinum compounds. However, the platinum compounds are generally not classified as hepatotoxic drugs").
Rubbia-Brandt L, Audard V, Sartoretti P, Roth AD, Brezault C, Le Charpentier M, Dousset B, et al. (2004). Severe hepatic sinusoidal obstruction associated with oxaliplatin-based chemotherapy in patients with metastatic colorectal cancer. Ann Oncol. (Among 153 patients undergoing hepatic resection for colon cancer, centrolobular congestion and necrosis was found in nontumor liver tissue in 51% of those who received neoadjuvant chemotherapy, but in none undergoing surgery alone; oxaliplatin as the most frequently implicated agent; follow up biopsies often showed fibrosis).
Sebagh M, Plasse M, Lévi F, Adam R. (2005). Severe hepatic sinusoidal obstruction and oxaliplatin-based chemotherapy in patients with metastatic colorectal cancer: a real entity?. Ann Oncol. (Letter in response to Rubbia-Brandt [2004] questioning the clinical significance of the histological findings; among 700 patients treated "mainly" by oxaliplatin, the authors mention no increase in operative mortality).
Tisman G, MacDonald D, Shindell N, Reece E, Patel P, Honda N, Nishimora EK, et al. (2004). Oxaliplatin toxicity masquerading as recurrent colon cancer. J Clin Oncol. (69 year old man with adenocarcinoma of the rectum developed ascites after radiation and a fourth course of chemotherapy with capecitabine and oxaliplatin, with a hepatic venous pressure gradient of 18 mm Hg and liver biopsy showing sinusoidal obstruction syndrome and no cirrhosis [bilirubin and Alk P elevated but ALT normal], with progressive hepatic and multiorgan failure and death).
Fernandez FG, Ritter J, Goodwin JW, Linehan DC, Hawkins WG, Strasberg SM. (2005). Effect of steatohepatitis associated with irinotecan or oxaliplatin pretreatment on resectability of hepatic colorectal metastases. J Am Coll Surg. (Among patients undergoing hepatic resections for colorectal cancer metastases, steatohepatitis and liver injury was more common among the 14 who received oxaliplatin and/or irinotecan than 10 who received 5-FU alone or 13 given no chemotherapy).
Rubbia-Brandt L, Mentha G, Terris B. (2006). Sinusoidal obstruction syndrome is a major feature of hepatic lesions associated with oxaliplatin neoadjuvant chemotherapy for liver colorectal metastases. J Am Coll Surg. (Letter in response to Fernandez [2005] suggesting that some of the hepatic changes represented sinusoidal obstruction syndrome).
Aloia T, Sebagh M, Plasse M, Karam V, Lévi F, Giacchetti S, Azoulay D, et al. (2006). Liver histology and surgical outcomes after preoperative chemotherapy with fluorouracil plus oxaliplatin in colorectal cancer liver metastases. J Clin Oncol. (Among 92 patients undergoing resection of colorectal liver metastases, those who received chemotherapy [mostly oxaliplatin and fluorouracil] were more likely to have vascular changes, but had similar rates of steatosis compared to those who did not receive chemotherapy).
Vauthey JN, Pawlik TM, Ribero D, Wu TT, Zorzi D, Hoff PM, Xiong HQ, et al. (2006). Chemotherapy regimen predicts steatohepatitis and an increase in 90-day mortality after surgery for hepatic colorectal metastases. J Clin Oncol. (Among 406 patients undergoing hepatic resection for colorectal metastases, preoperative chemotherapy with oxaliplatin was associated with sinusoidal dilatation [19% vs 2%], whereas irinotecan was associated with steatohepatitis [20% vs 4.4%] which was associated with higher 90 day mortality rates).
Karoui M, Penna C, Amin-Hashem M, Mitry E, Benoist S, Franc B, Rougier P, et al. (2006). Influence of preoperative chemotherapy on the risk of major hepatectomy for colorectal liver metastases. Ann Surg. (Retrospective analysis of 67 patients undergoing hepatic resection of colorectal liver metastasis, found preoperative chemotherapy was associated with higher rates of complications [38% vs 14%] and hepatic failure [11% vs 0%] compared to no chemotherapy, despite no difference in degree of elevation of liver tests during first 10 postoperative days).
Higashiyama H, Harabayashi T, Shinohara N, Chuma M, Hige S, Nonomura K. (2007). Reactivation of hepatitis in a bladder cancer patient receiving chemotherapy. Int Urol Nephrol. (A 59 year old woman with bladder cancer who was an HBV carrier developed severe reactivation of hepatitis B after 2 cycles of chemotherapy with methotrexate, epiadriamycin and cisplatin, resolving with lamivudine and prednisolone therapy).
Zorzi D, Laurent A, Pawlik TM, Lauwers GY, Vauthey J-N, Abdalla EK. (2007). Chemotherapy-associated hepatotoxicity and surgery for colorectal liver metastases. Brit J Surg. (Systematic review of liver toxicity occurring after preoperative systemic chemotherapy for colorectal liver metastases, oxaliplatin has been linked to histological changes in microvasculature of the liver but not with increased mortality rate or hepatic failure).
Liao Y, Lu X, Lu C, Li G, Jin Y, Tang H. (2008). Selection of agents for prevention of cisplatin-induced hepatotoxicity. Pharmacol Res. (Analysis of factors that decreased hepatotoxicity of cisplatin in animal model found antioxidants and glutathione precursors were effective in decreasing ALT elevations during therapy).
Schouten van der Velden AP, Punt CJ, Van Krieken JH, Derleyn VA, Ruers TJ. (2008). Hepatic veno-occlusive disease after neoadjuvant treatment of colorectal liver metastases with oxaliplatin: a lesson of the month. Eur J Surg Oncol. (54 year old man with colon cancer metastatic to liver underwent attempt at resection followed by 11 cycles of chemotherapy [5-fluorouracil, and oxaliplatin] and repeat hepatic resection, but developed liver failure and died postoperatively, autopsy showing absence of central hepatic vein in the area of the resected tumor).
Morris-Stiff G, Tan YM, Vauthey JN. (2008). Hepatic complications following preoperative chemotherapy with oxaliplatin or irinotecan for hepatic colorectal metastases. Eur J Surg Oncol. (Systematic review of the literature on oxaliplatin and liver injury; histological vascular changes with sinusoidal damage occurs in at least 20% of patients treated with oxaliplatin, but it is not associated with an increase in mortality in most studies).
Khan AZ, Morris-Stiff G, Makuuchi M. (2009). Patterns of chemotherapy-induced hepatic injury and their implications for patients undergoing liver resection for colorectal liver metastases. J Hepatobiliary Pancreat Surg. (Review of liver injury from neoadjuvant therapy of colon cancer metastases; oxaliplatin is frequently associated with sinusoidal injury, but rarely with clinically significant SOS).
Brouquet A, Benoist S, Julie C, Penna C, Beauchet A, Rougier P, Nordlinger B. (2009). Risk factors for chemotherapy-associated liver injuries: A multivariate analysis of a group of 146 patients with colorectal metastases. Surgery. (Analysis of factors predictive of steatosis, steatohepatitis and sinusoidal dilatation in liver tissue from 146 patients undergoing liver resection of colorectal metastases found that oxaliplatin based chemotherapy was a risk factor for sinusoidal changes [Hazard ratio 4.4]).
Kudo D, Tsutsumi S, Akasaka H, Jin H, Ohashi T, Muroya T, Hasebe T, et al. (2009). Gan To Kagaku Ryoho. (Abstract only: Among 47 patient undergoing hepatic resections for metastatic colorectal cancer, sinusoidal dilation but not steatohepatitis was more common among those who received preoperative oxaliplatin chemotherapy).
van den Broek MA, Olde Damink SW, Driessen A, Dejong CH, Bemelmans MH. (2009). Nodular regenerative hyperplasia secondary to neoadjuvant chemotherapy for colorectal liver metastases. Case Rep Med. (Two men, ages 68 and 51 years, developed nodular regenerative hyperplasia after 6 cycles of oxaliplatin/capecitabine with minimal liver test abnormalities [bilirubin 2.3 and 1.2 mg/dL, ALT 23 and 57 U/L, Alk P 237 and 205 U/L], one dying of hepatic failure after partial hepatectomy of residual tumor, and the second developing variceal hemorrhage and encephalopathy after one resection but eventually recovering and tolerating a repeat hepatic resection 18 months later).
Cleary JM, Tanabe KT, Lauwers GY, Zhu AX. (2009). Hepatic toxicities associated with the use of preoperative systemic therapy in patients with metastatic colorectal adenocarcinoma to the liver. Oncologist. (Review of hepatic complications of oxaliplatin chemotherapy for colorectal cancer; sinusoidal dilation reported in 10-61% of patients sometimes with greater postoperative morbidity, but with no greater mortality).
Slade JH, Alattar ML, Fogelman DR, Overman MJ, Agarwal A, Maru DM, Coulson RL, et al. (2009). Portal hypertension associated with oxaliplatin administration: clinical manifestations of hepatic sinusoidal injury. Clin Colorectal Cancer. (Six patients developed noncirrhotic portal hypertension after 6 to 12 cycles of oxaliplatin and 5-FU chemotherapy [6-15 months] for metastatic colorectal cancer, including 3 men, 3 women, ages 37 to 69 years, all of whom developed thrombocytopenia [53-128,000/µL], splenomegaly and varices, 2 with variceal hemorrhage and 2 with ascites).
McDonald GB. (2010). Hepatobiliary complications of hematopoietic cell transplantation, 40 years on. Hepatology. (Review of liver complications of bone marrow [hematopoietic cell] transplantation, which have become less frequent with better understanding of their causes and means of prevention; the rate of SOS has decreased because of avoidance of more aggressive ablative therapies [total body irradiation and high doses of cyclophosphamide] and better understanding of pharmacokinetics of the alkylating agents).
Soubrane O, Brouquet A, Zalinski S, Terris B, Brézault C, Mallet V, Goldwasser F, Scatton O. (2010). Predicting high grade lesions of sinusoidal obstruction syndrome related to oxaliplatin-based chemotherapy for colorectal liver metastases: correlation with post-hepatectomy outcome. Ann Surg. (Among 78 patients undergoing resection of hepatic metastases from colon cancer after oxaliplatin neoadjuvant therapy, vascular changes occurred in 46 [59%] and 5 had fibrosis; AST elevations occurred in 61% of patients with vascular changes and 25% of those without).
Pessaux P, Chenard MP, Bachellier P, Jaeck D. (2010). Consequences of chemotherapy on resection of colorectal liver metastases. J Visc Surg. (Review of the role and liver toxicity of chemotherapy for colorectal metastases; oxaliplatin is associated with sinusoidal injury and irinotecan with chemotherapy induced steatohepatitis [CASH]).
Takamoto T, Hashimoto T, Sano K, Maruyama Y, Inoue K, Ogata S, Takemura T, et al. (2010). Recovery of liver function after the cessation of preoperative chemotherapy for colorectal liver metastasis. Ann Surg Oncol. (Indocyanine green [ICG] testing of 55 patients receiving chemotherapy before hepatic resection for colorectal cancer metastases showed improvements in ISG clearance within 4 weeks of stopping therapy).
Ryan P, Nanji S, Pollett A, Moore M, Moulton CA, Gallinger S, Guindi M. (2010). Chemotherapy-induced liver injury in metastatic colorectal cancer: semiquantitative histologic analysis of 334 resected liver specimens shows that vascular injury but not steatohepatitis is associated with preoperative chemotherapy. Am J Surg Pathol. (Among 334 patients undergoing hepatic resection for colorectal cancer metastases, marked hepatic steatosis was uncommon [9%] and correlated with BMI rather than chemotherapy, while sinusoidal lesions were present in 35% of cases and correlated with oxaliplatin use; neither correlated with immediate operative outcome).
Overman MJ, Maru DM, Charnsangavej C, Loyer EM, Wang H, Pathak P, Eng C, et al. (2010). Oxaliplatin-mediated increase in spleen size as a biomarker for the development of hepatic sinusoidal injury. J Clin Oncol. (Spleen size as measured by CT increased [by an average of 22%] in 86% of 96 patients treated with oxaliplatin and 5FU for colorectal cancer and correlated with thrombocytopenia and sinusoidal injury seen on subsequent liver biopsy of 60 patients).
Komori H, Beppu T, Baba Y, Horino K, Imsung C, Masuda T, Hayashi H, et al. (2010). Histological liver injury and surgical outcome after FOLFOX followed by a hepatectomy for colorectal liver metastases in Japanese patients. Int J Clin Oncol. (Comparison of 15 patients who received oxaliplatin to 12 who received no chemotherapy before hepatic resection of metastatic colorectal cancer showed higher rates of marked sinusoidal dilatation [33% vs 8%] and “blue liver” [47% vs 0%], but similar rates of steatosis [40% vs 33%] in oxaliplatin treated subjects).
Heo J, Shin KY, Kwon YH, Park SY, Jung MK, Cho CM, Tak WY, Kweon YO. (2011). Korean J Gastroenterol. (Abstract only: 35 year old woman developed portal hypertension after 12 cycles of oxaliplatin for rectal cancer).
Makowiec F, Möhrle S, Neeff H, Drognitz O, Illerhaus G, Opitz OG, Hopt UT, zur Hausen A. (2011). Chemotherapy, liver injury, and postoperative complications in colorectal liver metastases. J Gastrointest Surg. (Among 102 patients undergoing hepatic resections for colorectal cancer metastases, steatosis was most common in those who had preoperative chemotherapy regardless of regimen [46% vs 18%], but BMI was a stronger risk factor and steatosis did not correlate with poor outcome; none of 22 patients who received oxaliplatin died or developed hepatic insufficiency).
Tamandl D, Klinger M, Eipeldauer S, Herberger B, Kaczirek K, Gruenberger B, Gruenberger T. (2011). Sinusoidal obstruction syndrome impairs long-term outcome of colorectal liver metastases treated with resection after neoadjuvant chemotherapy. Ann Surg Oncol. (Among 199 patients undergoing hepatic resection for colorectal metastases, findings of hepatic steatosis did not correlate with decreased survival, whereas severe sinusoidal lesions [found in 18% of oxaliplatin recipients vs 6% of controls] were associated with markedly reduced survival).
Vincenzi B, Daniele S, Frezza AM, Berti P, Vespasiani U, Picardi A, Tonini G. (2012). The role of S-adenosylmethionine in preventing oxaliplatin-induced liver toxicity: a retrospective analysis in metastatic colorectal cancer patients treated with bevacizumab plus oxaliplatin-based regimen. Support Care Cancer. (Among 78 patients with metastatic colon cancer who received 3 cycles of oxaliplatin, capecitabine and bevacizumab with or without S-adenosyl-methionine [SAMe], those on SAMe had lower peak ALT levels [98 vs 179 U/L] and less frequent discontinuations).
Nam SJ, Cho JY, Lee HS, Choe G, Jang JJ, Yoon YS, Han HS, et al. (2012). Chemotherapy-associated hepatopathy in Korean colorectal cancer liver metastasis patients: oxaliplatin-based chemotherapy and sinusoidal injury. Korean J Pathol. (Among 89 patients with colorectal cancer undergoing hepatic resection for metastases, sinusoidal dilation, centrolobular fibrosis, small vessel obliteration and hepatocyte plate disruption were more frequent after oxaliplatin than fluorouracil chemotherapy and correlated with number of cycles).
Viganò L, Ravarino N, Ferrero A, Motta M, Torchio B, Capussotti L. (2012). Prospective evaluation of accuracy of liver biopsy findings in the identification of chemotherapy-associated liver injuries. Arch Surg. (Prospective study of 100 patients with colorectal cancer and hepatic metastases found liver biopsy was accurate in demonstrating marked steatosis [>30%] but not in detecting sinusoidal dilation [28% in oxaliplatin recipients] or steatohepatitis [19% in irinotecan recipients]).
Robinson SM, Wilson CH, Burt AD, Manas DM, White SA. (2012). Chemotherapy-associated liver injury in patients with colorectal liver metastases: a systematic review and meta-analysis. Ann Surg Oncol. (Systematic review of literature on chemotherapy induced liver injury in patients with colorectal cancer; oxaliplatin in regimens are associated with a higher rate of sinusoidal injury [17% vs 6%] but not steatosis [11.5% vs 9.8%], and rates are reduced by concurrent bevacizumab therapy).
Vreuls CP, Van Den Broek MA, Winstanley A, Koek GH, Wisse E, Dejong CH, Olde Damink SW, et al. (2012). Hepatic sinusoidal obstruction syndrome (SOS) reduces the effect of oxaliplatin in colorectal liver metastases. Histopathology. (Among 50 patients with hepatic resection for colorectal cancer after 1 to 12 cycles [mean = 6] of oxaliplatin, 32 [64%] had changes of sinusoidal obstruction syndrome among whom tumor regression scores were reduced compared to patients without the sinusoidal histological changes; no discussion of survival).
Robinson SM, White SA. (2012). Hepatic sinusoidal obstruction syndrome reduces the effect of oxaliplatin in colorectal liver metastases. Histopathology. (Editorial in response to Vreuls [2012]).
Bissonnette J, Généreux A, Côté J, Nguyen B, Perreault P, Bouchard L, Pomier-Layrargues G. (2012). Hepatic hemodynamics in 24 patients with nodular regenerative hyperplasia and symptomatic portal hypertension. J Gastroenterol Hepatol. (Among 24 patients with various forms of nodular regenerative hyperplasia [NRH], wedged hepatic venous pressure gradients [HVPG: range 2 to 17, mean=8.9 mm Hg] were lower than directly obtained portal venous pressure gradients [range 16 to 35, mean=20.5 mmHg], indicating that HVPG measurements are inaccurate in NRH).
Jardim DL, Rodrigues CA, Novis YA, Rocha VG, Hoff PM. (2012). Oxaliplatin-related thrombocytopenia. Ann Oncol. (Review of thrombocytopenia related to oxaliplatin therapy which has three possible causes: myelosuppression, immune destruction or portal hypertension and liver disease).
Pilgrim CH, Thomson BN, Banting S, Phillips WA, Michael M. (2012). The developing clinical problem of chemotherapy-induced hepatic injury. ANZ J Surg. (Review of types of liver injury from chemotherapy; oxaliplatin is associated with vascular and sinusoidal injury whereas irinotecan is linked to steatohepatitis).
Benavides M, Pericay C, Valladares-Ayerbes M, Gil-Calle S, Massutí B, Aparicio J, Dueñas R, et al. (2012). Oxaliplatin in combination with infusional 5-fluorouracil as first-line chemotherapy for elderly patients with metastatic colorectal cancer: a phase II study of the Spanish Cooperative Group for the Treatment of Digestive Tumors. Clin Colorectal Cancer. (Among 129 elderly patients with metastatic colorectal cancer treated with oxaliplatin and fluorouracil, 21 [16%] had ALT or AST elevations, but levels >5 times ULN occurred in only 3 [2%]).
Narita M, Oussoultzoglou E, Chenard MP, Fuchshuber P, Rather M, Rosso E, Addeo P, et al. (2012). Liver injury due to chemotherapy-induced sinusoidal obstruction syndrome is associated with sinusoidal capillarization. Ann Surg Oncol. (Among 98 patients with colorectal cancer undergoing hepatic resection for metastases, 39 [36 of whom had received oxaliplatin] had changes of SOS and degree of changes correlated with isocyanine green [ICG] retention and overexpression of CD34 indicating capillarization of hepatic sinusoids).
Vietor NO, George BJ. (2012). Oxaliplatin-induced hepatocellular injury and ototoxicity: a review of the literature and report of unusual side effects of a commonly used chemotherapeutic agent. J Oncol Pharm Pract. (46 year old woman with colorectal cancer developed ototoxicity and marked ALT elevations [~850 U/L] during cycle 2 of fluorouracil, oxaliplatin and leucovorin, that resolved when oxaliplatin was held, and then recurred despite a reduced dose of oxaliplatin).
Agostini J, Benoist S, Seman M, Julié C, Imbeaud S, Letourneur F, Cagnard N, et al. (2012). Identification of molecular pathways involved in oxaliplatin-associated sinusoidal dilatation. J Hepatol. (Analysis of differences in gene expression in livers of patients with and without sinusoidal dilation after oxaliplatin therapy identified increased expression of genes involved with angiogenesis, inflammation and collagen production in response to sinusoidal injury).
Hoff PM, Saad ED, Costa F, Coutinho AK, Caponero R, Prolla G, Gansl RC. (2012). Literature review and practical aspects on the management of oxaliplatin-associated toxicity. Clin Colorectal Cancer. (Review of adverse effects of oxaliplatin including hepatotoxicity which appears to be due to sinusoidal cell injury).
Tsimberidou AM, Leick MB, Lim J, Fu S, Wheler J, Piha-Paul SA, Hong D, et al. (2013). Dose-finding study of hepatic arterial infusion of oxaliplatin-based treatment in patients with advanced solid tumors metastatic to the liver. Cancer Chemother Pharmacol. (Among 76 patients with hepatic metastases of different cancers given hepatic artery infusions of oxaliplatin [369 cycles], 26 [34%] had ALT elevations [5% were >5 times ULN] and 11 [14%] had bilirubin elevations).
van den Broek MA, Vreuls CP, Winstanley A, Jansen RL, van Bijnen AA, Dello SA, Bemelmans MH, et al. (2013). Hyaluronic acid as a marker of hepatic sinusoidal obstruction syndrome secondary to oxaliplatin-based chemotherapy in patients with colorectal liver metastases. Ann Surg Oncol. (Among 40 patients with colorectal cancer undergoing hepatic resection for metastases after oxaliplatin based chemotherapy, 23 had SOS which was severe in 11 patients who had higher hyaluronic acid levels than the 29 with mild or no injury [52 vs 29 ng/mL]).
Rahbari NN, Weitz J. (2013). Hyaluronic acid as a marker of sinusoidal obstruction syndrome after oxaliplatin-based chemotherapy for colorectal liver metastases: Don't forget the tumor. Ann Surg Oncol. (Editorial in response to van den Broek [2013]).
Hubert C, Sempoux C, Humblet Y, van den Eynde M, Zech F, Leclercq I, Gigot JF. (2013). Sinusoidal obstruction syndrome (SOS) related to chemotherapy for colorectal liver metastases: factors predictive of severe SOS lesions and protective effect of bevacizumab. HPB (Oxford). (Retrospective analysis of 151 patients with colorectal cancer and hepatic metastases; SOS occurred in 60 of 67 [90%] of those who received oxaliplatin and fluorouracil alone and was severe in 37 [55%], but arose in only 6 of 10 who received both oxaliplatin and bevacizumab and was severe in only 1 [10%]).
Wolf PS, Park JO, Bao F, Allen PJ, DeMatteo RP, Fong Y, Jarnagin WR, et al. (2013). Preoperative chemotherapy and the risk of hepatotoxicity and morbidity after liver resection for metastatic colorectal cancer: a single institution experience. J Am Coll Surg. (Among 506 patients undergoing hepatic resection for colorectal cancer, histologic evaluation of non-tumor parenchyma showed that steatohepatitis was associated with irinotecan regimens, higher BMI and diabetes, whereas sinusoidal dilatation was not associated with chemotherapy; neither chemotherapy or liver histology correlated with complications or deaths).
Urdzik J, Bjerner T, Wanders A, Duraj F, Haglund U, Norén A. (2013). Magnetic resonance imaging flowmetry demonstrates portal vein dilatation subsequent to oxaliplatin therapy in patients with colorectal liver metastasis. HPB (Oxford). (Prospective monitoring by magnetic resonance imaging found that oxaliplatin chemotherapy was associated with portal vein dilatation independent of sinusoidal injury, but that a combination of measurements of portal velocity and cross sectional area was predictive of the finding of sinusoidal injury).
Béchade D, Désolneux G, Fonck M, Soubeyran I, Bécouarn Y, Evrard S. (2013). Presse Med. (Two cases of NRH in a man and woman, age 60 years, with metastatic colorectal cancer after 17 and 12 courses of oxaliplatin based chemotherapy).
Vreuls CP, Olde Damink SW, Koek GH, Winstanley A, Wisse E, Cloots RH, van den Broek MA, et al. (2013). Glutathione S-transferase M1-null genotype as risk factor for SOS in oxaliplatin-treated patients with metastatic colorectal cancer. Br J Cancer. (Among 55 patients with metastatic colorectal cancer who received oxaliplatin chemotherapy, the glutathione S-transferase [GST] M1-null polymorphism was frequent in those who developed moderate or severe sinusoidal injury [12 of 17: 70%] than in those with no or mild injury [13 of 38: 34%]).
Ogata H, Gushima T, Maruoka S, Takasaki S, Tanaka R, Matsuura T, Aishima S, et al. (2013). A case of portal hypertension after 5-fluorouracil, leucovorin, and oxaliplatin (mFOLFOX6) chemotherapy. Nihon Shokakibyo Gakkai Zasshi. (46 year old man developed noncirrhotic portal hypertension after 10 cycles of oxaliplatin and fluorouracil for colorectal cancer metastases, and required endoscopic ligation and transvenous obliteration of bleeding esophageal varices).
Uchino K, Fujisawa M, Watanabe T, Endo Y, Nobuhisa T, Matsumoto Y, Kai K, et al. (2013). Oxaliplatin-induced liver injury mimicking metastatic tumor on images: a case report. Jpn J Clin Oncol. (47 year old man developed radiologically apparent hepatic masses after 6 cycles of oxaliplatin and fluorouracil for metastatic colorectal cancer which, on resection, were not tumors but represented severe sinusoidal dilatation and congestion).
Lu QY, Zhao AL, Deng W, Li ZW, Shen L. (2013). Hepatic histopathology and postoperative outcome after preoperative chemotherapy for Chinese patients with colorectal liver metastases. World J Gastrointest Surg. (Retrospective analysis of 106 patients undergoing hepatic resection for colorectal cancer at a single Chinese medical center over a 10 year period, found that oxaliplatin based regimens were associated with sinusoidal dilation [42%] compared to surgery only controls [21%], but perioperative complication rates were similar).
Nguyen-Khac E, Lobry C, Chatelain D, Fuks D, Joly JP, Brevet M, Tramier B, et al. (2013). A Reappraisal of chemotherapy-induced liver injury in colorectal liver metastases before the era of antiangiogenics. Int J Hepatol. (Among 50 patients with colorectal cancer undergoing hepatectomy after chemotherapy, 55% of those who received oxaliplatin developed sinusoidal dilatation and 23% had evidence of NRH compared to 23% and 6% of controls; however, there was no difference in overall mortality or outcomes).
Schwarz RE, Berlin JD, Lenz HJ, Nordlinger B, Rubbia-Brandt L, Choti MA. (2013). Systemic cytotoxic and biological therapies of colorectal liver metastases: expert consensus statement. HPB (Oxford). (Summary of current optimal therapies of patients with colorectal liver metastases and the problem of chemotherapy associated liver injury, particularly to oxaliplatin [SOS, NRH] and irinotecan [steatosis] leading to recommendation that, if possible, preoperative chemotherapy be limited to 3 months).
Morine Y, Shimada M, Utsunomiya T. (2014). Evaluation and management of hepatic injury induced by oxaliplatin-based chemotherapy in patients with hepatic resection for colorectal liver metastasis. Hepatol Res. (Review of the frequency, clinical significance and management of hepatic effects of oxaliplatin therapy in patients undergoing liver resection for colorectal cancer metastases).
Morris-Stiff G, White AD, Gomez D, Cameron IC, Farid S, Toogood GJ, Lodge JP, et al. (2014). Nodular regenerative hyperplasia (NRH) complicating oxaliplatin chemotherapy in patients undergoing resection of colorectal liver metastases. Eur J Surg Oncol. (Retrospective review of 978 patients who underwent hepatic resection for colorectal cancer metastases at a single institution in the UK between 2000 and 2010, identified 5 who developed clinically apparent NRH, all had received at least 6 cycles of oxaliplatin and fluorouracil, but only 1 had hepatic failure which was reversible and the all deaths [n=4] were due to cancer recurrence).
Seo AN, Kim H. (2014). Sinusoidal obstruction syndrome after oxaliplatin-based chemotherapy. Clin Mol Hepatol. (58 year old Korean woman with metastatic colon cancer underwent 6 cycles of chemotherapy with capecitabine and oxaliplatin and subsequent hemihepatectomy, the normal liver showing marked SOS despite normal liver tests [bilirubin 0.8 mg/dL, ALT 12 U/L, Alk P 60 U/L, INR 1.1] indicating the frequent silent nature of SOS).
Nalbantoglu IL, Tan BR, Linehan DC, Gao F, Brunt EM. (2014). Histological features and severity of oxaliplatin-induced liver injury and clinical associations. J Dig Dis. (Among 47 patients with metastatic colon cancer undergoing liver resection after oxaliplatin based chemotherapy, 32 [68%] had changes indicative of SOS [using a scoring system of 0 to 4], which was moderate or severe in 26 [55%] and usually associated with serum aminotransferase abnormalities; liver also showing capillarization, sinusoidal fibrosis and hepatocyte proliferation).
Tajima H, Ohta T, Miyashita T, Nakanuma S, Matoba M, Miyata T, Sakai S, et al. (2015). Oxaliplatin-based chemotherapy induces extravasated platelet aggregation in the liver. Mol Clin Oncol. (Analysis of 32 patients with metastatic colorectal cancer undergoing hepatic resection demonstrated lower platelet counts [167,000 vs 227,000/µL], larger spleen volumes, and prominent aggregation of platelets in zone 3 in those who had received adjuvant oxaliplatin [n=17] vs controls [n=15]).
Viganò L, Rubbia-Brandt L, De Rosa G, Majno P, Langella S, Toso C, Mentha G, et al. (2015). Nodular regenerative hyperplasia in patients undergoing liver resection for colorectal metastases after chemotherapy: risk factors, preoperative assessment and clinical impact. Ann Surg Oncol. (Among 406 patients undergoing 478 liver resections for metastatic colorectal cancer at two European medical centers between 2015 and 2017, 68% had sinusoidal dilatation, 25% had steatosis, 10% had steatohepatitis and 18% had NRH, risk factors for NRH being preoperative oxaliplatin and low platelet counts but not routine liver test abnormalities).
Choi JH, Won YW, Kim HS, Oh YH, Lim S, Kim HJ. (2016). Oxaliplatin-induced sinusoidal obstruction syndrome mimicking metastatic colon cancer in the liver. Oncol Lett. (22 year old woman with resected colon cancer presented after 5 cycles of adjuvant chemotherapy with minor liver test abnormalities [bilirubin 0.6 mg/dL, ALT 51 U/L, Alk P 105 U/L] and enlarging nodular hepatic lesions on abdominal CT which at surgery were areas of dark red congested liver which represented areas of severe SOS histologically).
Stevenson HL, Prats MM, Sasatomi E. (2017). Chemotherapy-induced sinusoidal injury (CSI) score: a novel histologic assessment of chemotherapy-related hepatic sinusoidal injury in patients with colorectal liver metastasis. BMC Cancer. (Immunohistochemistry done on 30 liver samples from hepatic resections for metastatic colorectal cancer found aberrant CD34 staining [marker for platelets] more frequently in 22 cases with SOS vs 8 controls [82% vs 25%] as well as multifocal increases in smooth muscle actin staining [72% vs 25%] and glutamine synthetase staining [32% vs none]; the combination of the 3 stains being possibly helpful in diagnosis of SOS).
Vigano L, De Rosa G, Toso C, Andres A, Ferrero A, Roth A, Sperti E, et al. (2017). Reversibility of chemotherapy-related liver injury. J Hepatol. (Among 15 patients with colorectal cancer who underwent two hepatic resections more than 270 days apart without interval chemotherapy, SOS regressed in 4 of 5 patients who had SOS initially and NRH in 7 of 8 patients, whereas neither steatosis [3 of 3] or steatohepatitis [2 of 2] resolved).
Duwe G, Knitter S, Pesthy S, Beierle AS, Bahra M, Schmelzle M, Schmuck RB, et al. (2017). Hepatotoxicity following systemic therapy for colorectal liver metastases and the impact of chemotherapy-associated liver injury on outcomes after curative liver resection. Eur J Surg Oncol. (Review of the hepatotoxicity of chemotherapies for metastatic colorectal cancer, focusing on fluorouracil [steatosis], irinotecan [steatohepatitis] and oxaliplatin [SOS] and including analysis of the contribution of anti-EGFR antibodies and bevacizumab on both efficacy and safety).
Wakiya T, Kudo D, Ishido K, Kimura N, Yakoshi Y, Toyoki Y, Kijima H, et al. (2017). Effect of age on the development of chemotherapy-associated liver injury in colorectal cancer liver metastasis. Mol Clin Oncol. (Among 64 patients with metastatic colorectal cancer receiving oxaliplatin-based adjuvant chemotherapy, sinusoidal injury occurred in 27-30% and steatohepatitis in 35-40% of patients, rates being similar in all age groups).
Bernichon E, Daguenet E, Molla C, Cornillon J, Lejeune C, Casteillo F, Guyotat D, et al. (2018). Sinusoidal obstruction syndrome/veno-occlusive disease complication in lymphoma patients treated with oxaliplatin-based regimen: A case series report. Curr Res Transl Med. (Among 49 patients with lymphoma receiving autologous hematopoietic cell transplantation over a 2 year period at a single, French referral center, 4 of 19 who had received oxaliplatin-based cycles of chemotherapy developed severe SOS within 2-9 days compared to none of 30 who did not receive oxaliplatin).
Shigefuku R, Watanabe T, Mizukami T, Matsunaga K, Hattori N, Ehira T, Suzuki T, et al. (2018). Esophagogastric varices were diagnosed in a non-cirrhotic liver case during long-term follow-up after oxaliplatin-based chemotherapy. Clin J Gastroenterol. (78 year old Japanese man presented with esophageal varices and splenomegaly 3.5 years after receiving 10 cycles of oxaliplatin and fluorouracil for metastatic colorectal cancer [bilirubin1.0, ALT 16 U/L, Alk P 269 U/L, platelets 65,000/µL], liver biopsy showing no evidence of fibrosis).
Overman MJ, Ferrarotto R, Raghav K, George B, Qiao W, Machado KK, Saltz LB, et al. (2018). The addition of bevacizumab to oxaliplatin-based chemotherapy: impact upon hepatic sinusoidal injury and thrombocytopenia. J Natl Cancer Inst. (Among 184 patients with metastatic colorectal cancer treated with adjuvant fluorouracil and oxaliplatin with or without bevacizumab, the rate of splenomegaly and thrombocytopenia in follow up was less in those receiving bevacizumab).
Gutierrez L, Méndez S, Mitjavila M, Llop E, Salas C, Ruiz-Casado A. (2019). Noncirrhotic portal hypertension: an under-reported late adverse event of SIRT in metastatic colorectal cancer patients. J Cancer Res Ther. (Three patients with metastatic colorectal cancer developed noncirrhotic portal hypertension after cycles of fluorouracil and oxaliplatin and then selective internal radiation therapy with 90-yttrium-radiolabeled microspheres, two later dying of hepatic failure).
Corbacioglu S, Jabbour EJ, Mohty M. (2019). Risk factors for development of and progression of hepatic veno-occlusive disease/sinusoidal obstruction syndrome. Biol Blood Marrow Transplant. (Review of the risks, clinical features and management of chemotherapy induced SOS focusing upon oxaliplatin and the more recent causes, gemtuzumab ozogamicin and inotuzumab ozogamicin).
Hisaka T, Ishikawa H, Sakai H, Kawahara R, Goto Y, Nomura Y, Yasunaga M, et al. (2019). Sinusoidal obstruction syndrome and postoperative complications resulting from preoperative chemotherapy for colorectal cancer liver metastasis. Anticancer Res. (Among 90 cases of metastatic colorectal cancer treated with adjuvant chemotherapy before hepatic resection, rates of sinusoidal injury in the resected nontumorous liver were similar in those who received no monoclonal antibody vs bevacizumab or cetuximab or panitumumab [50% to 51%], but the degree of injury appeared less with bevacizumab).
Wilcox MA, Hardin J, Weaver J, Voss EA. (2019). Liver test monitoring: real-world compliance for drugs with monitoring requirements at 2-week intervals or more frequently. Pharmaceut Med. (Analysis of 3 large health databases for compliance with recommendations for liver test monitoring when initiating therapy with 9 drugs found compliance was highest for oxaliplatin [75%], somewhat lower for rifampin [68%], tolcapone [67%], albendazole [66%] and azathioprine [61%], and poor for pentamidine [21%], felbamate [22%], succimer [29%] and ketoconazole [32%]).
Fujii A, Tateoka T, Okuyama T, Matsushima J, Sato T, Ono Y, Ban S. (2020). Uneven distribution of histologic changes of "blue liver" induced after oxaliplatin-based chemotherapy for colon cancer. Int J Surg Pathol. (50 year old woman with metastatic colorectal cancer underwent 8 courses of oxaliplatin and capecitabine followed by hepatic resection that revealed mottled red areas of the nontumorous liver with changes of SOS).
Honda S, Tsujimoto M, Minegaki T, Mori T, Muraoka J, Nishiguchi K. (2020). A case of idiosyncratic liver injury after oxaliplatin-induced thrombocytopenia. J Clin Pharm Ther. (46 year old woman with metastatic colorectal carcinoma experienced an anaphylactic reaction to a second infusion of oxaliplatin with subsequent abnormal liver tests [bilirubin 0.8 rising to 1.4 mg/dL, ALT 110 to 1010 U/L, Alk P 281 to 313 U/L], with profound thrombocytopenia [7000/µL] and rapid resolution within 2-3 weeks with prednisone therapy).
Puente A, Fortea JI, Del Pozo C, Huelin P, Cagigal ML, Serrano M, Cabezas J, et al. (2019). Porto-sinusoidal vascular disease associated to oxaliplatin: an entity to think about it. Cells. (Review of NRH arising after oxaliplatin therapy including possible pathogenesis, criteria for diagnosis and recommendations for management).
Debureaux PE, Febvre de Nailly DL, Tavernier E, Bedoui M, Kuhnowski F, Tamburini J, et al. (2020). Sinusoidal obstruction syndrome: a warning about autologous stem cell transplantation preceded by regimens containing oxaliplatin. Bone Marrow Transplant. (Among 23 patients with SOS after autologous HCT for lymphoma identified in a French national survey, 21 had received oxaliplatin compared to only 13 of 23 matched controls).
Eren T, Pasaoglu L. (2020). Splenomegaly in colon cancer during adjuvant oxaliplatin-based chemotherapy. Cureus. (Among 50 patients with metastatic colorectal cancer who received fluorouracil and oxaliplatin between 2015 and 2017, 50% developed splenomegaly [>50% increase in spleen size by CT], which correlated best with total oxaliplatin dose received and development of thrombocytopenia after therapy).
Morioka D, Izumisawa Y, Yamaguchi K, Sato K, Komiyama S, Nakagawa K, Kakizoe M, et al. (2020). Surgical intervention for portal hypertension caused by oxaliplatin-based chemotherapy: a case report and a review of literature regarding radiological and/or surgical interventions for oxaliplatin-associated portal hypertension. Clin J Gastroenterol. (63 year old man developed recurrent variceal hemorrhage, ascites and hydrothorax after oxaliplatin therapy of metastatic colon cancer followed by hepatic resection who was treated with splenectomy and portocaval shunt, with resolution of the complications of portal hypertension).
Al-Qudah G, Ghanem M, Blebea J, Shaheen S. (2020). Blue liver: case report of blue liver. Am J Case Rep. (39 year old man with acute cholestatic liver disease of unknown cause [bilirubin 14 to 21 mg/dL, ALT 185 U/L, Alk P 150 U/L INR 1.2] was found to have a blue liver on laparoscopic cholecystectomy, later improving on long term ursodiol therapy; no exposure to oxaliplatin and blue color not explained; jaundice possibly due to unacknowledged anabolic steroid use).
Di Federico A, Nuvola G, Sisi M, Lenzi B, Nobili E, Campana D. (2020). Hyperammonemic encephalopathy during XELOX regimen. is it capecitabine or oxaliplatin responsible?. Anticancer Drugs. (65 year old man with refractory metastatic lung carcinoid tumor developed confusion and coma 11 days into a 3-week regimen of capecitabine [1.6 mg/m2 daily for 15 days] and oxaliplatin [104 mg/m2 on day 1] with ammonia of 167 µmol/L but normal bilirubin and aminotransferase levels, resolving within 3 days of stopping capecitabine).

## OTHER REFERENCE LINKS

1 Recent References on Oxaliplatin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Oxaliplatin/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Oxaliplatin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Oxaliplatin)